# Margetuximab

Short Chapter

[Preliminary review chapter based on the FDA Product Labeling and Integrated Review only.]

## OVERVIEW

### Introduction

Margetuximab is a monoclonal antibody to HER2 used in combination with chemotherapy for treatment of adults with advanced, relapsed or refractory HER2-positive breast cancer. Margetuximab therapy is associated with transient serum aminotransferase elevations during therapy in as many as one-third of patients but has not been linked to instances of clinically apparent liver injury.

### Background

Margetuximab (mar” je tux’ i mab) is a mouse-human chimeric, cytolytic monoclonal antibody to human epidermal growth factor receptor-2 (HER2) that is used to treat adults with relapsed or refractory HER2-positive cancer. HER2 is a cell surface receptor that is overexpressed in approximately 20% of breast cancers. Engagement of the receptor induces pathways that promote cell proliferation and growth. Margetuximab was found to be cytolytic to HER2 positive cancer cells in culture and resulted in objective response rates in a proportion of adults with relapsed or refractory advanced breast cancer. Margetuximab was granted accelerated approval in 2020 for patients with HER2 positive breast cancer after treatment with at least two previous anti-HER2 therapies such as trastuzumab, trastuzumab-emtansine, and pertuzumab or in combination with a tyrosine kinase inhibitor of HER2 such as lapatinib, tucatinib, or neratinib. Margetuximab is available in solution in single dose vials of 250 mg in 10 mL (25 mg/mL) under the brand name Margenza. The recommended dose is 15 mg/kg intravenously every 3 weeks, the first dose infused over 120 minutes and subsequent doses over 30 minutes. Premedication with acetaminophen, antihistamines, and corticosteroids is recommended to prevent serious infusion reactions. In prelicensure trials, adverse events were common and included infusion reactions, fatigue, nausea and vomiting, diarrhea, constipation, abdominal pain, fever, peripheral neuropathy, cough, decreased appetite, arthralgia, alopecia, and hand-foot syndrome. Laboratory abnormalities included decreases in hemoglobin, white blood cell counts, and platelets and increases in serum creatinine, ALT AST, alkaline phosphatase and lipase. These common adverse events and abnormalities were similar in frequency with trastuzumab as with margetuximab and chemotherapy. Severe adverse reactions included severe infusion related reactions, febrile neutropenia, left ventricular dysfunction, and embryo-fetal toxicity. Margetuximab should only be administered by health care personnel with experience, expertise, and facilities capable of managing the complications of cancer chemotherapy.

### Hepatotoxicity

Margetuximab was compared to trastuzumab both combined with chemotherapy in a large, controlled trial involving 536 patients with advanced, relapsed or refractory HER2 positive breast cancer and previous therapy with at least two anti-HER2 directed regimens. The objective response rate was 22% with margetuximab vs 19% with trastuzumab, and both the frequency and pattern of adverse events were similar between the two regimens. The two groups had similar rates of total and severe adverse events. Furthermore, “there were no clinically meaningful differences between treatment groups in laboratory values over time or toxicity grade shifts for any hematology, chemistry, coagulation, or urinalysis parameter.” Serum ALT elevations arose in 32% vs 30% and were 5 times ULN in 2% vs 0.8%. There were no cases of clinically apparent liver injury with jaundice in either group, and no deaths from liver failure. Since its approval in 2020, there have been no published reports of clinically apparent liver injury attributable to margetuximab therapy, although clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of the frequent liver test abnormalities during margetuximab therapy are not known but were likely due to the underlying metastatic cancer or to the other chemotherapeutic agents that were used with margetuximab.

### Outcome and Management

The product label for margetuximab does not recommend monitoring of routine liver tests during therapy, and considerations of the severity of the underlying tumor and its poor prognosis generally outweigh concerns about serum aminotransferase elevations not accompanied by jaundice or symptoms of liver injury.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Margetuximab – Margenza®

DRUG CLASS

Antineoplastic agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Margetuximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Margetuximab | 1350624-75-7 (https://pubchem.ncbi.nlm.nih.gov/substance/381127049) | Monoclonal Antibody | Not Available

## SELECTED BIBLIOGRAPHY

References updated: 12 July 2024

Abbreviations: ULN, upper limit of the normal range.

[Short Chapter information is based largely on FDA Product Labeling and the FDA Integrated Review accessible from the FDA website https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm. All other references have not been fully reviewed and annotated.]

FDA. Integrated Review. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761150Orig1s000MultidisciplineR.pdf (FDA summary data on the safety and efficacy of margetuximab, submitted in support of the application for approval as therapy of metastatic HER2 positive breast cancer).
Rugo HS, Im SA, Cardoso F, Cortés J, Curigliano G, Musolino A, Pegram MD, et al.; SOPHIA Study Group. Efficacy of margetuximab vs tastuzumab in patients with pretreated ERBB2-positive advanced breast cancer: a phase 3 randomized clinical trial. JAMA Oncol. 2021;7:573-584.33480963
Markham A. Margetuximab: first approval. Drugs. 2021;81:599-604.33761116
Martínez-Sáez O, Prat A. Current and future management of HER2-positive metastatic breast cancer. JCO Oncol Pract. 2021;17:594-604.34077236
Royce M, Osgood CL, Amatya AK, Fiero MH, Chang CJG, Ricks TK, Shetty KA, et al. FDA Approval summary: margetuximab plus chemotherapy for advanced or metastatic HER2-positive breast cancer. Clin Cancer Res. 2022;28:1487-1492.34916216
Margetuximab (Margenza) for HER2-positive breast cancer. Med Lett Drugs Ther. 2022;64:e195-e196.36397195
Rugo HS, Im SA, Cardoso F, Cortes J, Curigliano G, Musolino A, Pegram MD, et al.; SOPHIA Study Group. Margetuximab versus trastuzumab in patients with previously treated HER2-positive advanced breast Cancer (SOPHIA): final overall survival results from a randomized phase 3 trial. J Clin Oncol. 2023;41:198-205.36332179

## OTHER REFERENCE LINKS

1. Recent References on Margetuximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Margetuximab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Margetuximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Margetuximab)